# Acebutolol

## OVERVIEW

### Introduction

Acebutolol is a cardioselective beta-blocker used in the treatment of hypertension, angina pectoris and cardiac arrhythmias. Acebutolol has been linked to several instances of clinically apparent drug induced liver injury.

### Background

Acebutolol (a" se bue' toe lol) is considered a “selective” beta-adrenergic receptor blocker in that it has potent activity against beta-1 adrenergic receptors which are found in cardiac muscle, but has little or no activity against beta-2 adrenergic receptors found on bronchial and vascular smooth muscle. Acebutolol also has mild sympathomimetic activity (a partial adrenergic agonist, similar to pinolol). Acebutolol was approved for use in the United States in 1985 and is currently used in the therapy of hypertension alone or in combination with other agents. It is also used for cardiac arrhythmias. Acebutolol is available in capsules of 200 and 400 mg in generic forms and under the trade name Sectral. The usual initial oral dose of acebutolol in adults is 200 mg once or twice daily, with subsequent adjustment based upon clinical response and tolerance; the usual maintenance dosage being 200 to 1200 mg daily. Common side effects include bradycardia, hypotension, fatigue, dizziness, depression, insomnia, memory loss and impotence. In high doses, acebutolol is less cardioselective and can induced acute bronchospasm. As with other beta-blockers, sudden withdrawal can trigger rebound hypertension.

### Hepatotoxicity

Acebutolol is associated with a low rate of mild-to-moderate elevations of serum aminotransferase levels during treatment. These enzyme elevations are usually asymptomatic and transient and resolve even with continuation of therapy. There have been few documented cases of clinically apparent, acute liver injury attributed to acebutolol. The time to onset of injury was typically between 1 and 6 weeks of starting. The pattern of liver enzyme elevations was usually hepatocellular with an acute hepatitis-like presentation, although some cases present with a mixed pattern of enzymes. Fever commonly accompanied the liver injury, but usually without rash and eosinophia. Acebutolol is known to induce autoantibodies such as antinuclear antibody in 10% to 30% of patients, some of whom develop a lupus-like syndrome with fatigue, skin rash and arthralgias. Serum enzyme elevations may accompany this syndrome, but jaundice and symptoms of liver injury are uncommon. The published cases of hepatotoxicity due to acebutolol were relatively mild, self-limited and recovery was rapid upon stopping. Rechallenge resulted in rapid recurrence of injury.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of drug induced liver injury from beta-blockers such as acebutolol is not known. Acebutolol is extensively metabolized by the liver and excreted as inactive metabolites. The few cases of clinically apparent liver injury attributed to acebutolol were likely idiosyncratic.

### Outcome and Management

The severity of liver injury due to beta-blockers ranges from mild serum aminotransferase elevations to acute hepatitis with jaundice. Acebutolol has not been implicated in cases of acute liver failure or vanishing bile duct syndrome. In large case series of drug induced liver injury and acute liver failure due to medications, acebutolol has not been listed as a potential cause. There is little information about cross reactivity among the beta-blockers to hepatic injury. Switching from a beta-blocker that has caused acute liver injury to another should be done with caution and active monitoring.

References to the safety and potential hepatotoxicity of acebutolol are provided in the overview on Beta-Adrenergic Receptor Antagonists, last updated in June 2019.

Drug Class: Beta-Adrenergic Receptor Antagonists

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Acebutolol – Generic, Sectral®

DRUG CLASS

Beta-Adrenergic Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=acebutolol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Acebutolol | 37517-30-9 | C18-H28-N2-O4 | Acebutolol Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Acebutolol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Acebutolol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Acebutolol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Acebutolol)